# Opioids, Opioid Antagonists

## OVERVIEW

### Introduction

The opioids are a large class of medications related in structure to the natural plant alkaloids found in opium that are derived from the resin of the opium poppy, Papaver somniferum. The natural alkaloids are also referred to as opiates and include morphine and codeine. Synthetic derivatives include heroin, fentanyl, hydromorphone, methadone, buprenorphine and others. The opioids are highly potent and effective analgesics, but most have a high potential for dependency and abuse.

Opioids act by engagement of specific cell surface receptors; the opiate receptors, which are designated µ [mu], κ [kappa] and δ [delta]. These receptors are found predominantly in the central nervous system, brain and spinal column, but are also present on vascular, cardiac, lung, gut and even peripheral blood mononuclear cells. Engagement of the opiate receptors generates a series of intracellular signals, including inhibition of adenylate cyclase, decreased opening of calcium channels, increased potassium currents and activation of protein kinase C (PKC). The major effect of these pathways is reduction in cell excitability and neurotransmission. The natural ligands for the opiate receptors are the so-called endogenous opioid peptides such as the enkephalins, endorphins and endomorphins.

The opioids have a variety of clinical effects, but are predominantly known and used for their profound pain relieving effects. Other effects that are often linked to opiate analgesia include euphoria, changes in mood, drowsiness and mental clouding. However, the distinctive feature of the analgesia induced by the opioids is the lack of loss of consciousness. The pain is often described as less intense, but still present although better tolerated. Thus, the opioids do not decrease or treat the cause of the painful stimulus, but rather decrease its perception.

Other effects of opioids include respiratory depression, decreased gastrointestinal motility, sedation, nausea, vomiting, constipation and intestinal bloating. Opioids also have direct cardiovascular effects, decreasing blood pressure, causing vasodilation and decreasing cardiac work.

Most opioids have similar effects and side effects, although pharmacokinetic differences, tissue distribution, and receptor type specificity probably account for the variation in effects of the various synthetic and semisynthetic derivatives of morphine. Morphine is considered the prototype opiate, against which other agents are measured for their analgesic effects as well as adverse side effects.

The opioids can be categorized into subclasses on the basis of their chemical structure as opium alkaloids (opiates: codeine, morphine), semisynthetic derivatives of the natural alkaloids (hydrocodone, hydromorphone, oxycodone, buprenorphine), and various classes of synthetic opioids such as the anililopiperidines (fentanyl, alfentanil, sufentanil, remifentanil), diphenylpropylamine derivatives (propoxyphene, dextropropoxyphene, methadone, diphenoxylate, loperamide), and others (pentazocine, butorphanol, nalbuphine, levorphanol, tramadol), and, the opioid antagonists (nalmefene, naloxone and naltrexone). They can also be informally classified based upon their major use such as anesthesia (fentanyl, alfentanil, remifentanil, sufentanil), severe pain (morphine, hydromorphone, levorphanol, meperidine), moderate-to-severe acute or chronic pain (transdermal or transbuccal fentanyl, codeine, oxycodone, hydrocodone, levorphanol, methadone), diarrhea (loperamide, diphenoxylate), and cough (codeine, hydrocodone). Finally, opioids can be categorized on the basis of their action as full agonists, partial agonists or mixed agonists/antagonists, and antagonists of opiate receptors.

Opioid receptor antagonists are used to reverse the effects of opioids and are invaluable in the management of opioid overdose (naloxone, naltrexone, nalmefene). Specialized opioid antagonists can be used to reverse unwanted opioid effects, such as constipation in patients with chronic pain on long-term opioids. These agents (naldemedine, naloxegol) are generally modified so as not to cross the blood brain and reverse the central nervous system effects of opiates.

Opioids are rare causes of drug induced liver disease and are not mentioned in large case series of clinically apparent liver injury caused by medications. In physiological, pain relieving doses, opioids have not been implicated in causing clinically apparent liver injury, acute liver failure, chronic hepatitis or vanishing bile duct syndrome. However, overdoses of the more potent opioids have been linked to cases of acute liver injury, usually with a precipitous onset and pattern of acute toxicity with marked elevations in serum aminotransferase levels and early onset of signs of hepatic failure. This syndrome has been best characterized after buprenorphine overdose or abuse, but likely occurs with others. It is possible that the implicated opioids are not directly toxic to the liver, but cause ischemic liver injury due to respiratory failure, cardiovascular collapse, shock and anoxia that can occur with severe opioid overdose. The clinical syndrome resembles acute hepatic necrosis and liver failure, but is rapidly reversible and rarely the primary cause of death from overdose.

A special form of liver injury linked to opioid use occurs with their fixed drug combinations with acetaminophen. These combinations are commonly used for moderate to moderately severe pain and can lead to abuse. If taken too frequently, acetaminophen doses may reach toxic levels, particularly with overuse for several days in the face of malnutrition, alcohol abuse or intercurrent illness. These other stresses can lower hepatic glutathione levels and predispose to acetaminophen hepatotoxicity. This constellation of events is referred to as inadvertent or unintended acetaminophen overdose or more colloquially as a “therapeutic misadventure”. Because of their potential for hepatotoxicity, opioid combinations in which the dose of acetaminophen is greater than 325 mg per tablet or capsule were discontinued.

References to the safety and hepatotoxic potential of the various opiate agonists are given together at the end of this overview section. References to the opioids and the opiate antagonists used to treat substance abuse are given separately with each agent (buprenorphine, methadone, nalmefene, naloxone, naltrexone). The opioids are discussed individually or as groups of agents and links to each are given below.

Full and partial agonists:

• Alfentanil

• Buprenorphine

• Butorphanol

• Codeine

• Diphenoxylate

• Fentanyl

• Heroin

• Hydrocodone

• Hydromorphone

• Levorphanol

• Loperamide

• Meperidine

• Methadone

• Morphine

• Oliceridine

• Opium

• Oxycodone

• Oxymorphone

• Pentazocine

• Remifentanil

• Sufentanil

• Tramadol

Opiate antagonists:

• Naldemedine

• Nalmefene

• Naloxegol

• Naloxone

• Naltrexone

## ANNOTATED BIBLIOGRAPHY

References updated: 24 November 2020

Zimmerman HJ. Narcotic analgesics. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 710-11. (Expert review of hepatotoxicity published in 1999 discusses morphine, heroin, methadone and codeine, mentioning that studies in humans "have shown little evidence of hepatic injury").
Larrey D, Ripault MP. Illegal and recreational compounds. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 456-7. (Review of hepatotoxicity discusses buprenorphine, an orally available morphine analogue, which has been linked to cases of severe acute liver injury, usually as a result of intravenous administration).
Yaksh T, Wallace M. Opioids, analgesia, and pain management. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 355-386. (Textbook of pharmacology and therapeutics).
Edland JF. Liver disease in heroin addicts. Hum Pathol 1972; 3: 75-84. (Review of autopsy findings in the liver of heroin addicts mentions the frequency of nonspecific portal inflammation, lymph node enlargement in the porta hepatis, typical changes of viral hepatitis including subacute hepatic necrosis with 3 representative case histories). 5060682
Stimmel B, Vernace S, Tobias H. Hepatic dysfunction in heroin addicts. The role of alcohol. JAMA 1972; 222: 811-2. (Among 46 heroin users admitted for methadone maintenance, 85% admitted to excessive alcohol intake, and 10 of 12 patients with unexplained liver test abnormalities had changes of alcoholic hepatitis on liver biopsy). 4677931
Ireton HJ, Gust ID, Moon WJ, Lehmann N, Stening GF, Smallwood RA. The covert liver disease of drug addicts. Aust N Z J Med 1974; 4: 444-9. (Among 20 injection drug users, 11 [55%] had abnormal liver tests [AST 41-98 U/L] and 19 [95%] had abnormalities on liver biopsy, often being mild; none of the patients had HBsAg in serum). 4532912
Gorodetzky CW, Sapira JD, Jasinski DR, Martin WR. Liver disease in narcotic addicts. I. The role of the drug. Clin Pharmacol Ther 1968; 9: 720-4. (20 male prison inmates were given morphine daily for 6-8 months and then switched to methadone that was slowly withdrawn; monthly testing demonstrated that serum ALT and AST values did not change appreciably during periods of morphine or methadone administration). 5721975
Sapira JD, Jasinski DR, Gorodetzky CW. Liver disease in narcotic addicts. II. The role of the needle. Clin Pharmacol Ther 1968; 9: 725-39. (Among 32 prison inmates with a history of heroin use, 26 [81%] had some clinical or biochemical evidence of liver disease, and the frequency of chronic hepatitis increased with number of years of injection use). 5721976
Lapierre J. Possible hepatotoxic effect of methadone. Can Med Assoc J 1969; 101: 113. (Long term heroin user developed nausea and dizziness within a week of starting methadone with atypical lymphocytosis; liver tests were not done until after stopping methadone and then showed minor abnormalities only [bilirubin normal, ALT 56 U/L, Alk P normal]; no further follow up available). 5794138
Tartakow IJ. Narcotic-induced hepatitis. Am J Med 1971; 50: 313-6. (Among 1015 cases of viral hepatitis reported in one county in NY over a 3 year period, 162 were believed to be serum hepatitis, of which 107 [66%] occurred in injection drug users). 5553950
Kreek MJ, Dodes L, Kane S, Knobler J, Martin R. Long-term methadone maintenance therapy: effects on liver function. Ann Intern Med 1972; 77: 598-602. (Among 214 patients with opioid dependency treated with maintenance methadone therapy for up to 3 years, there were no significant changes in liver tests and no deaths from liver disease). 4629927
Seeff LB. Hepatitis in the drug abuser. Med Clin North Am 1975; 59: 843-8. (Review of the frequency and clinical features of viral hepatitis in injection drug users, including the frequency of chronic hepatitis and history of multiple bouts of hepatitis, only one of which is associated with HBsAg positivity). 1095845
Gelb AM, Mildvan D, Stenger RJ. The spectrum and causes of liver diseases in narcotic addicts. Am J Gastroenterol 1977; 67: 314-8. (Among 42 heroin users with liver disease, 79% were also heavy alcohol users and all 17 patients with cirrhosis also abused alcohol, suggesting that alcohol plays a major role in serious liver disease among drug users). 879147
Vandelli C, Piaggi V, Battilani R, Cariani E, Sirotti MA. Relationship between HBV markers and heroin as a cause of liver injury in drug addicts. Drug Alcohol Depend 1984; 14: 129-33. (Among 50 injection drug users admitted to start methadone maintenance who had liver tests abnormalities and underwent liver biopsy, 36 had chronic active hepatitis, 4 had chronic persistent hepatitis, and 10 had nonspecific reactive changes, and all 23 patients with HBsAg in serum had chronic active hepatitis). 6510216
Joehl RJ, Koch KL, Nahrwold DL. Opioid drugs cause bile duct obstruction during hepatobiliary scans. Am J Surg 1984; 147: 134-8. (32 year old woman with abdominal pain and fever treated with meperidine had an abnormal hepatobiliary scan, but on subsequent laparotomy had a normal biliary system without gallstones; in subsequent volunteer studies, opioid drugs caused delayed clearance of technetium labeled iminodiacetic acid and scans suggested bile duct obstruction). 6537876
Bickel WK, Stitzer ML, Bigelow GE, Liebson IA, Jasinski DR, Johnson RE. A clinical trial of buprenorphine: comparison with methadone in the detoxification of heroin addicts. Clin Pharmacol Ther 1988; 43: 72-8. (Among 45 patients with opioid dependency treated with either buprenorphine or methadone for up to 90 days, no discussion of side effects or ALT levels). 3275523
de Araújo MS, Gerard F, Chossegros P, Porto LC, Barlet P, Grimaud JA. Vascular hepatotoxicity related to heroin addiction. Virchows Arch A Pathol Anat Histopathol 1990; 417 (6): 497-503. (Histological analysis of liver biopsies from 39 injection drug users with ALT elevations found sinusoidal dilatation and centro-lobular inflammation were more prominent in actively using compared to previous heroin users, but fibrosis was less). 2125388
Drummer OH, Opeskin K, Syrjanen M, Cordner SM. Methadone toxicity causing death in ten subjects starting on a methadone maintenance program. Am J Forensic Med Pathol 1992; 13: 346-50. (Among patients starting methadone maintenance who died acutely, the cause of death was respiratory depression in 5 patients and, while all ten had chronic hepatitis, liver disease did not appear to be the cause in any). 1288269
Thompson DR. Narcotic analgesic effects on the sphincter of Oddi: a review of the data and therapeutic implications in treating pancreatitis. Am J Gastroenterol 2001; 96: 1266-72. (Systematic review of the literature on the effects of opioids on sphincter of Oddi spasm, found little difference among the various opioids in causing an increase in sphincter pressure or symptomatic pancreatitis; recommending use of morphine for pain management, even in acute pancreatitis). 11316181
Economou G, Ward-McQuaid JN. A cross-over comparison of the effect of morphine, pethidine, pentazocine, and phenazocine on biliary pressure. Gut 1971; 12: 218-21. (Among 31 patients after cholecystectomy with T tubes, morphine, meperidine and pentazocine caused increased bile duct pressure; no mention of abnormal liver tests). 4928171
Johnson RE, Jaffe JH, Fudala PJ. A controlled trial of buprenorphine treatment for opioid dependence. JAMA 1992; 267: 2750-5. (Trial comparing buprenorphine vs two doses of methadone for opioid dependence for 17 weeks found no serious adverse events in either group; no mention of liver injury or ALT elevations). 1578593
Clark RF, Wei EM, Anderson PO. Meperidine: therapeutic use and toxicity. J Emerg Med 1995; 13: 797-802. Review. (Review of the efficacy and safety of meperidine, a synthetic opioid used in emergency departments; it has variable absorption and bioavailability and toxicities include seizures and neuropsychiatric reactions, making it a second line agent for treatment of severe pain). 8747629
Ling W, Wesson DR, Charuvastra C, Klett CJ. A controlled trial comparing buprenorphine and methadone maintenance in opioid dependence. Arch Gen Psychiatry 1996; 53: 401-7. (Among 225 patients with opioid dependency treated with either buprenorphine or two doses of methadone over a one year period, adverse events were similar in both groups and there were no serious liver related events). 8624183
Petry NM, Bickel WK, Piasecki D, Marsch LA, Badger GJ. Elevated liver enzyme levels in opioid-dependent patients with hepatitis treated with buprenorphine. Am J Addict 2000; 9: 265-9. (Among 120 opioid dependent patients treated with buprenorphine, ALT and AST levels did not change in patients whose levels were normal initially, but increased slightly in those with preexisting abnormalities [median ALT increase=8 U/L]). 11000922
Mattick RP, Ali R, White JM, O'Brien S, Wolk S, Danz C. Buprenorphine versus methadone maintenance therapy: a randomized double-blind trial with 405 opioid-dependent patients. Addiction 2003; 98: 441-52. (Controlled trial in 405 patients with opioid dependence found similar rates of adverse events with buprenorphine and methadone; one patient had hepatitis C, but no other liver related adverse events reported). 12653814
Ho V, Stewart M, Boyd P. Cholestatic hepatitis as a possible new side-effect of oxycodone: a case report. J Med Case Rep 2008; 2: 140. (A 34 year old man developed jaundice 6 weeks after outpatient surgery and while receiving oxycodone [bilirubin 8.2 mg/dL, ALT 295 U/L, Alk P 358 U/L], having received cephalosporin at the time of surgery, with slow but ultimately complete recovery). 18452597
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease collected in the US between 2003 and 2008, no cases were attributed to an opioid analgesic). 18955056
Pinto H, Maskrey V, Swift L, Rumball D, Wagle A, Holland R. The SUMMIT trial: a field comparison of buprenorphine versus methadone maintenance treatment. J Subst Abuse Treat 2010; 39: 340-52. (Patient preference controlled trial comparing buprenorphine and methadone for up to 6 months in 361 opiate dependent subjects; no discussion of hepatotoxicity or ALT elevations). 20817384
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none to methadone or other opiates or agents used to treat substance abuse). 20949552
Gibson A, Randall D, Degenhardt L. The increasing mortality burden of liver disease among opioid-dependent people: cohort study. Addiction 2011; 106: 2186-92. (Among 2489 people enrolled in methadone maintenance programs in Australia between 1980 and 1985 who were tracked using the National Death Index, the standardized mortality rate was increased compared to the general population [SMR = 4.6] and 17% of deaths were due to liver disease [SMR 28 for women and 14.5 for men]). 21749525
Saxon AJ, Ling W, Hillhouse M, Thomas C, Hasson A, Ang A, Doraimani G, et al. Buprenorphine/Naloxone and methadone effects on laboratory indices of liver health: a randomized trial. Drug Alcohol Depend 2013; 128: 71-6. (Among 731 patients with opioid dependency treated with either buprenorphine and naloxone vs methadone for at least 24 weeks, 12.6% vs 17.9% developed ALT elevations [>2 times ULN] which were "extreme" in only 2.1% vs 3.6% [bilirubin 0.7-3.7 mg/dL, ALT 418-6280 U/L], usually attributable to underlying HBV or HCV infection). 22921476
Drugs for pain. Treat Guidel Med Lett 2013; 11(128): 31-42. (Concise summary and recommendations for use of analgesics including aspirin, acetaminophen, NSAIDs, opiates and adjuvant pain medications; no mention of liver related adverse events). 23518635
Nalamachu S, Rauck RL, Hale ME, Florete OG Jr, Robinson CY, Farr SJ. A long-term, open-label safety study of single-entity hydrocodone bitartrate extended release for the treatment of moderate to severe chronic pain. J Pain Res 2014; 7: 669-78. (Open label study of 638 patients with chronic pain symptoms treated with extended release hydrocodone in varying doses found a greater than 50% improvement in pain scores in 40% of patients and “no clinically meaningful changes from baseline were observed in blood chemistry”). 25473308
Lucas GM, Young A, Donnell D, Richardson P, Aramrattana A, Shao Y, Ruan Y, Liu W, et al.; HPTN 058 study group. Hepatotoxicity in a 52-week randomized trial of short-term versus long-term treatment with buprenorphine/naloxone in HIV-negative injection opioid users in China and Thailand. Drug Alcohol Depend 2014; 142: 139-45. (Among 1036 patients with opioid use disorder treated with buprenorphine/naloxone in short [18 day] or long [52 week] courses, serum ALT elevations above 3 times ULN arose in 76 patients [7%], most instances occurring with either acute or chronic HCV infection and rates of ALT elevations were similar with either short and long term use, as well as after discontinuation of the medication). 24999060
Naloxegol (Movantik) for opioid-induced constipation. Med Lett Drugs Ther 2015; 57 (1478): 135-7. (Concise review of the mechanism of action, efficacy and safety of naloxegol shortly after its approval for use in the US; mentions dose related gastrointestinal side effects, but not ALT elevations or hepatotoxicity). 26393826
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to opiates or opiate antagonists). 25754159
Feng G, Luo Q, Guo E, Yao Y, Yang F, Zhang B, Li L. Multiple organ dysfunction syndrome, an unusual complication of heroin intoxication: a case report and review of literature. Int J Clin Exp Pathol 2015; 8: 11826-30. (32 year old Chinese man was found unconscious after an opioid overdose and developed severe acidosis, respiratory failure and shock with evidence of cardiac, muscle, renal and hepatic injury [bilirubin not given, ALT 61 rising to 330 U/L, CPK 454 U/L, myoglobin 2000 ng/mL], with ultimate recovery, the liver injury most likely due to ischemic hepatitis). 26617935
Tetrault JM, Tate JP, Edelman EJ, Gordon AJ, Lo Re V 3rd, Lim JK, Rimland D, et al. Hepatic safety of buprenorphine in HIV-infected and uninfected patients with opioid use disorder: the role of HCV-infection. J Subst Abuse Treat 2016; 68: 62-7. (Among 666 patients [mostly men] identified in a Veterans Administration electronic medical database who were started on buprenorphine and were monitored, 14 developed “drug-induced liver injury”, all of whom had received a potentially hepatotoxic medication [93%] or had preexisting HCV infection [7%], and there was no overall “substantial” change in serum ALT, AST or bilirubin levels). 27431048
Pergolizzi JV, Raffa RB, Marcum Z, Colucci S, Ripa SR. Safety of buprenorphine transdermal system in the management of pain in older adults. Postgrad Med 2017; 129: 92-101. (Review of the literature on the safety and efficacy of buprenorphine in elderly patients mentions that liver abnormalities were rare [<1%] and ALT values above 3 times ULN occurred in 0.2% of both elderly and younger adults). 27929709
Ward A, Del Campo M, Hauser K. Complications with oxycodone and naloxone. Aust Prescr 2017; 40: 156-7. (Three patients on long term oxycodone who had significant liver dysfunction had symptoms of withdrawal probably due to increase in systemic levels of naloxone, but liver tests did not worsen). 28947855
Lau F, Gardiner M. Oxycodone/naloxone: An unusual adverse drug reaction. Aust Fam Physician 2017; 46: 42-3. (52 year old woman with chronic liver disease was switched from regular oxycodone to a fixed combination of oxycodone and naloxone and rapid developed withdrawal symptoms suspected to be due to the loss of first-pass clearance of naloxone by the liver dysfunction). 28189131
Cantrell FL, Sherrard J, Andrade M, Schaber B, McIntyre IM. A pediatric fatality due to accidental hydromorphone ingestion. Clin Toxicol (Phila) 2017; 55: 60-2. (3 year old boy was found to be dead and autopsy revealed no abnormalities except for presence of hydromorphone in blood and liver, his mother having a prescription for the drug found that several pills were missing). 27775447
Paul ABM, Simms L, Mahesan AM. Intentional heroin administration resulting in homicide in a 10-month old infant. Forensic Sci Int 2018; 290: e15-e18. (10 month of girl was found dead at home and autopsy revealed high levels of morphine in blood and liver as well as a single needle puncture mark in the left antecubital fossa; liver histopathology was referred to as unremarkable). 30017664
Opioids for pain. Med Lett Drugs Ther 2018; 60(1544): 57-64. (Concise review of the mechanism of action, efficacy, safety and costs of opioids used for pain relief, discusses adverse events or short and long term use, but makes no mention of ALT elevations or hepatotoxicity). 29664446
Concheiro M, Chesser R, Pardi J, Cooper G. Postmortem toxicology of new synthetic opioids. Front Pharmacol 2018; 9: 1210. (Summary of the chemical structures, pharmacology, relative potency and toxicology of the major synthetic opioids implicated in the ongoing opioid overdose epidemic; no discussion of hepatic injury). 30416445
Pattullo V, Pattullo GG, Strasser SI. Adverse effects of modified release oxycodone/naloxone in patients with moderate to severe liver impairment. Med J Aust 2018; 209: 279-80. (Letter stressing the complications of oxycodone/naloxone therapy in patients with moderate or severe liver impairment marked by a decrease in analgesic effect and risk of withdrawal symptoms due to systemic absorption and lack of hepatic clearance of naloxone, a potent opiate antagonist). 30208822
Kinnunen M, Piirainen P, Kokki H, Lammi P, Kokki M. Updated clinical pharmacokinetics and pharmacodynamics of oxycodone. Clin Pharmacokinet 2019; 58: 705-25. (Oxycodone is a full opioid agonist relatively selective for the µ receptor which is actively transported across the blood-brain barrier and is extensively metabolized by the liver via CYP3A4 [45%] and CYP 2D6 [29%], and plasma levels can be increased by CYP 3A4 inhibitors and renal dysfunction and to a lesser degree by CYP 2D6 inhibitors and hepatic dysfunction). 30652261